# Polygonum Multiflorum

## OVERVIEW

### Introduction

Polygonum multiflorum is an herb native to China, extracts of which has been used for centuries as a treatment for a wide range of conditions including backache, dizziness, liver disease, graying of the hair and constipation. P. multiflorum is also known as Shou Wu Pian, He Shou Pian, Fo-Ti and Chinese knotweed. Polygonum multiflorum has been implicated in numerous reports of clinically apparent acute liver injury which can be severe and even fatal.

### Background

Polygonum multiflorum is a commonly used and ancient Chinese herbal remedy prepared from the root of the tuber, Polygonum multiflorum, known as the Chinese climbing knotweed (Fo Ti). Fo Ti is a plant native to China which has been cultivated widely elsewhere, including the United States. Extracts of the roots of Polygonum multiflorum have been used for centuries in traditional Chinese medicine for a multitude of conditions and as an agent to prevent aging. Some of the historical uses include cancer, tuberculosis, diabetes, hypertension, infections, erectile dysfunction, infertility, and muscle soreness. It is also used as a tonic in liver and kidney conditions and to fortify muscles and bones. The extract has been marketed as a pill and claimed to be beneficial for headache, dizziness, graying of the hair, constipation and liver disease. Polygonum multiflorum can also be brewed in teas, and extracts are used in topical creams or ointments for skin conditions and muscle soreness. The efficacy of Polygonum multiflorum has not been proven in prospective, controlled trials but it is widely available over the counter. The active components of Polygonum multiflorum are believed to be anthraquinones including chrysophanol, emodin and rhein. Anthraquinones may also account for its effect in constipation but may also account for its hepatotoxicity. Various oral formulations are available, and it is also taken as a tea using extracts of dried Polygonum roots. Common side effects are abdominal pain, diarrhea, nausea and vomiting. Serious adverse events are rare, although hepatotoxicity has been increasingly reported, particularly from China and East Asia.

### Hepatotoxicity

Several published cases and a large case series from China, Korea and Japan of clinically apparent acute liver injury have been attributed to use of Polygonum multiflorum. Indeed, in China Polygonum multiflorum is reported to be the most common cause of herbal product related liver injury. The latency to onset is usually short, but ranges from a few days to as long as 6 months. The pattern of serum enzyme elevations is typically hepatocellular or mixed and the clinical presentation resembles acute viral hepatitis with onset of fatigue, nausea and right upper quadrant pain followed by dark urine and jaundice. Immunoallergic features are uncommon as are autoantibodies. Liver biopsy shows changes typical of acute hepatitis. The course is usually self-limited, resolving rapidly once the herbal is discontinued, but up to 10% of clinically apparent cases have been fatal or led to urgent liver transplantation. Recurrence upon re-exposure with a more rapid time to onset has been reported. Recent case series have identified the HLA allele B*35:01 as a risk factor, being found in 70% to 88% of cases compared to 5% of controls in Chinese populations. A similar HLA-association has been found for green tea in the United States.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of Polygonum multiflorum is not known, but the injury is usually attributed to the anthraquinones (such as emodin) which are major constituents in Polygonum multiflorum. In a single report, the major compound identified in the recovered tablets was a stilbene glycoside, tetrahydroxystilbene-glucopyranoside. The HLA allele B*35:01 appears to be a major risk factor for liver injury from Polygonum multiflorum suggesting that the injury is immunologically mediated.

### Outcome and Management

Hepatotoxicity from Polygonum multiflorum is usually self-limited but can be prolonged and is occasionally fatal. Recurrence with restarting the herb is common and rechallenge should be avoided. There is little evidence for cross sensitivity to the hepatotoxic effects of other herbal medications. Use of corticosteroids has not been reported to be effective.

Other Names: Fo Ti, Chinese climbing knotweed, Fleece-flower root, Chinese cornbind, Ho Shou Wu, Shou Wu Pian, Shen Min, Zi Shou Wu

Drug Class: Herbal and Dietary Supplements

Other herbals in the Subclass: Chinese and Other Asian Herbal Medicines

## CASE REPORT

### Case 1. Recurrent hepatitis due to Shou Wu Pian.(1)

A 5 year old girl developed jaundice and dark urine 4 months after her parents started her on Shou Wu Pian (3 tablets daily) for hair loss. She was otherwise healthy, with normal growth and development and no history of liver disease or risk factors for viral hepatitis. She was taking no conventional medications and her family initially did not mention the herbal use. Physical examination showed jaundice and mild hepatomegaly without fever, rash, abdominal tenderness or splenomegaly. Laboratory results showed raised serum bilirubin levels (4.9 mg/dL), and elevations in serum aminotransferases (ALT 1543 U/L, AST 1938 U/L) and gamma-glutamyl transpeptidase levels (GGT 67, normal <17 U/L). Tests for hepatitis A, B and C were negative as were tests for cytomegalovirus and Epstein Barr virus infection. Abdominal ultrasound showed normal liver and biliary tract. Liver tests improved without specific therapy and one month later liver tests were normal (Table). However, she returned with recurrence of jaundice 2 months later and at this point the history of herbal use was obtained. After recovering from the initial liver injury, the Shou Wu Pian had been restarted at a lower dose (2 tablets per day) and she redeveloped jaundice within a month of restarting. She again began to improve once the herbal medication was stopped, but liver test abnormalities did not completely resolve until 5 months later. Analysis of residual tablets of the Shou Wu Pian demonstrated the stilbene glycoside, tetrahydrostilbine-glucopyranoside, as the major constituent with only trace amounts of anthraquinones.

#### Key Points

Medication: | Shou Wu Pian (3 tablets daily)
Pattern: | Hepatocellular (R=9.8, using GGT instead of alkaline phosphatase)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 16 weeks initially, 4 weeks on re-exposure
Recovery: | 4 weeks initially, 21 weeks on re-exposure
Other medications: | None

#### Laboratory Values

Time After Starting | Months After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
| | Shou Wu Pian taken for hair loss for 4 months
4 months | 0 | 1543 | 67 | 4.9
5 months | 1 months | 50 | 21 | 0.4
| | Shou Wu Pian restarted for 1 month
7 (1) months | 0 | 1277 | 98 | 3.7
2 months | 1 months | 65 | 23 | 0.5
6 months | 5 months | 35 | 9 | 0.5
Normal Values | | <40 | <17 | <1.2

#### Comment

The case history is somewhat typical of herbal induced liver injury, in that the family did not inform the physicians that the child was receiving Shou Wu Pian (Polygonum multiflorum) and did not consider it harmful or imagine that it was the cause of the hepatitis. The clinical features resembled acute hepatitis, but the recurrence (with a shorter latency) on restarting the herbal makes this a convincing case for Polygonum multiflorum induced acute liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Shou Wu Pian – Generic

DRUG CLASS

Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Shou Wu Pian – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Shou Wu Pian | No Information | Herbal mixture | Not applicable

## CITED REFERENCE

1 Panis B, Wong DR, Hooymans PM, De Smet PAMG, Rosias PPR. (2005). Recurrent toxic hepatitis in a Caucasian girl related to the use of Shou-Wu-Pian, a Chinese herbal preparation. J Pediatr Gastroenterol Nutr.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 August 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of Chinese herbal products and teas are discussed generally without focus on Shou Wu Pian).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] discusses Chinese and other Asian herbal medicines including Shou Wu Pian [Polygonum multiflorum]).
Carlsson C. (1990). Herbs and hepatitis. Lancet. (Analysis of laboratory results from 395 patients found higher ALT levels among 53 patients taking herbals [55 U/L] than among those who did not [12 U/L]).
But PP, Tomlinson B, Lee KL. (1996). Hepatitis related to the Chinese medicine Shou-wu-pian manufactured from Polygonum multiflorum. Vet Hum Toxicol. (31 year old woman from Hong Kong developed jaundice several weeks after starting Shou Wu Pian for hair loss [bilirubin 4.0 rising to 6.1 mg/dL, ALT 870 U/L, Alk P 108 U/L], resolving within 3 weeks of stopping).
Park GJH, Mann SP, Ngu MC. (2001). Acute hepatitis induced by Shou-Wu-Pian, a herbal product derived from Polygonum multiflorum. J Gastroenterol Hepatol. (46 year old woman developed pruritus and jaundice 2 weeks after starting Shou Wu Pian [bilirubin 12.6 mg/dL, ALT 876 U/L, Alk P 185 U/L], resolving within a month of stopping).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Ernst E. (2002). Adulteration of Chinese herbal medicines with synthetic drugs: a systematic review. J Intern Med. (Systematic review of literature on adulteration of herbals with conventional medications, in 15 case reports and 2 cases series of 21 patients; contaminants included NSAIDs, corticosteroids, benzodiazepines, diuretics and antidiabetic medications, in up to 24% of products).
Mazzanti G, Battinelli L, Daniele C, Mastroianni CM, Lichtner M, Coletta S, Costantini S. (2004). New case of acute hepatitis following the consumption of Shou Wu Pian, a Chinese herbal product derived from Polygonum multiflorum. Ann Intern Med. (78 year old man developed jaundice 1 month after starting Shou Wu Pian for chronic prostatitis [bilirubin 25.5 mg/dL, ALT 1276 U/L, Alk P 409 U/L], resolving rapidly upon stopping).
Panis B, Wong DR, Hooymans PM, De Smet PAMG, Rosias PPR. (2005). Recurrent toxic hepatitis in a Caucasian girl related to the use of Shou-Wu-Pian, a Chinese herbal preparation. J Pediatr Gastroenterol Nutr. (5 year old girl developed jaundice 4 months after being started on Shou Wu Pian [bilirubin 4.9 mg/dL, ALT 1543 U/L, Alk P normal], resolving within 5 weeks and recurring within 4 weeks of restarting, resolving this second time only after 5 months: Case 1).
Yuen MF, Tam S, Fung J, Wong DK, Wong BC, Lai CL. (2006). Traditional Chinese medicine causing hepatotoxicity in patients with chronic hepatitis B infection: a 1-year prospective study. Aliment Pharmacol Ther. (Among 45 patients from Hong Kong with chronic hepatitis B who had an acute exacerbation of disease, the cause appeared to be an exacerbation of hepatitis B in 28, acute hepatitis A in 2, acute hepatitis E in 3, conventional drug induced liver injury in 3, alcohol in 2 and use of Traditional Chinese Medicines in 7, one of whom had been taking Polygonum multiflorum for weight loss for 6 weeks and developed a severe hepatitis, ultimately requiring liver transplantation).
Cárdenas A, Restrepo JC, Sierra F, Correa G. (2006). Acute hepatitis due to Shen-Min: a herbal product derived from Polygonum multiflorum. J Clin Gastroenterol. (28 year old woman developed fatigue followed by jaundice 8 weeks after starting Shen-Min for hair loss [bilirubin 12.3 mg/dL, ALT 2922 U/L, Alk P 153 U/L], resolving within 4 weeks of stopping the herbal).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, with a review of Chinese herbal medicines such as Chaso, Onshido, Sho-Saiko-To, Jin Bu Huan, Ma Huang and Shou Wu Pian).
Chitturi S, Farrell GC. (2008). Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol. (Review of hepatotoxicity of herbal medications focusing upon those used for weight loss, including nitrosofenfluramine, usnic acid, ephedra, germander, skullcap and green tea; other herbs discussed include Shou Wu Pian).
Laird AR, Ramchandani N, deGoma EM, Avula B, Khan IA, Gesundheit N. (2008). Acute hepatitis associated with the use of an herbal supplement (Polygonum multiflorum) mimicking iron-overload syndrome. J Clin Gastroenterol. (35 year old man developed jaundice “several months” after starting “NuHair” [containing Polygonum multiflorum] for hair loss [bilirubin 4.6 rising to 13.7 mg/dL, ALT 2714 U/L, Alk P 137 U/L, INR 1.3], resolving 4 months after stopping).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including Camellia sinensis, Cassia angustifolia, kava, valerian, Rhamnus purshianus, fitosoja, biosoja, Aesculus hippocatanum, chitosan, Couterea latifloral; no mention of Polygonum multiflorum).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbals or dietary supplements [HDS] but none specifically to Sho Wu Pian or a Polygonum multiflorum containing product).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines and usnic acid).
Wang YP, Shi B, Chen YX, Su J, Jiang CF, Xie WF. (2009). Drug-induced liver disease: an 8 year study of patients from one gastroenterological department. J Dig Dis. (Among 30 patients with drug induced liver disease seen at a single medical university in Shanghai between 2000-2008, 12 cases were attributed to Chinese herbs, but specific agents not discussed, 9 were jaundiced, 6 hepatocellular, 3 cholestatic and 2 mixed enzyme pattern elevations).
Cho HC, Min HJ, Ha CY, Kim HJ, Kim TH, Jung WT, Lee OJ, Bae IG. (2009). Reactivation of pulmonary tuberculosis in a patient with Polygonum multiflorum Thunb-induced hepatitis. Gut Liver. (34 year old man developed jaundice 30 days after starting daily use of Polygonum multiflorum tea and extract [bilirubin 25.3 mg/dL, ALT 1452 U/L, Alk P 111 U/L] with neutropenia [and pulmonary tuberculosis], liver injury resolving slowly after stopping herbal product).
Furukawa M, Kasajima S, Nakamura Y, Shouzushima M, Nagatani N, Takinishi A, Taguchi A, et al. (2010). Toxic hepatitis induced by show-wu-pian, a Chinese herbal preparation. Intern Med. (53 year old Japanese woman developed fatigue after taking Shou Wu Pian for 8 months [bilirubin 1.2 mg/dL, ALT 417 U/L, Alk P 1425 U/L, ANA 1:320], resolving within 2 months of stopping).
Valente G, Sanges M, Campione S, Bellevicine C, De Franchis G, Sollazzo R, Mattera D, et al. (2010). Herbal hepatotoxicity: a case of difficult interpretation. Eur Rev Med Pharmacol Sci. (35 year old Italian woman developed fatigue, abdominal pain and jaundice 4 weeks after starting 3 herbal products for hair loss including Shou Wu Pian [Polygonum multiflorum], glycyrrhizin and black cohosh [bilirubin 3.3 mg/dL, ALT 1540 U/L, Alk P 1020 U/L, normal INR], resolving within 2 months of stopping).
Bae SH, Kim DH, Bae YS, Lee KJ, Kim DW, Yoon JB, Hong JH, Kim SH. (2010). Korean J Hepatol. (54 year old Korean woman developed fatigue 1 month after starting Shou Wu [ALT 1136 U/L, Alk P 324 U/L], resolving rapidly but recurring upon re-exposure).
Jung KA, Min HJ, Yoo SS, Kim HJ, Choi SN, Ha CY, Kim HJ, et al. (2011). Drug-Induced Liver Injury: Twenty five cases of acute hepatitis following ingestion of Polygonum multiflorum Thunb. Gut Liver. (Case series of 25 patients with suspected hepatotoxicity from Polygonum multiflorum seen between 2007 and 2009 at a single Korean hospital; ages 24 to 65 years, presenting with jaundice after taking herbal as a tea or liquid extract for 2 to 180 days [bilirubin 1.6-32.9 mg/dL, ALT 271-1706 U/L, Alk P 81-465 U/L], injury pattern being hepatocellular [n=18] or mixed [n=7], liver biopsies showing acute hepatocellular injury, resolving in most, one patient died, one underwent liver transplantation, and one had recurrence on re-exposure).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon herbalife and hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids; Shou Wu Pian and Polygonum multiflorum not discussed).
Banarova A, Koller T, Payer J. (2012). Toxicka hepatitida po Polygonum multiflorum. Vnitr Lek. (33 year old woman developed nausea and jaundice 4 weeks after starting Polygonum multiflorum [bilirubin 6.1 mg/dL, ALT 1163 U/L, Alk P 131 U/L], resolving within 4 weeks of stopping).
Cortez E, Boulger C, Bernard A. (2012). Ban Tu Wan hepatotoxicity. BMJ Case Rep. (Middle aged Asian-American woman developed fatigue and confusion 2-3 months after starting an herbal mixture called Ban Tu Wan for hair loss [bilirubin 4.1 mg/dL, ALT 5386 U/L, Alk P 199 U/L], with coagulopathy and renal dysfunction progressing to hepatic failure and death within a few days; Ban Tu Wan was labelled as having 9 botanical ingredients including Polygonum multiflorum).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, including four reports of injury due to Polygonum multiflorum: Ho Shou Wu [Bae 2010], Shen Min [Cardenas 2006], and Shou Wu Pian [Jung 2011 and Panis 2005]).
Teschke R. (2014). Traditional Chinese Medicine induced liver injury. J Clin Transl Hepatol. (Review of literature on hepatotoxicity of traditional Chinese Medicines includes mention of cases attributed to Polygonum multiflorum and multiple products that include it: Shou Wu Pian, Shen Min, Ban Tu Wan and Ho Shou Wu]).
Dong H, Slain D, Cheng J, Ma W, Liang W. (2014). Eighteen cases of liver injury following ingestion of Polygonum multiflorum. Complement Ther Med. (Among 18 patients with Polygonum multiflorum [Fo-Ti] hepatotoxicity seen at a Chinese referral center between 2005 and 2012, median age was 42 years, latency 27 days [range 1-120 days], 16 [89%] with jaundice, all hepatocellular [ALT 601 to 4095 U/L, Alk P 89 to 816 U/L], all recovered and none died; frequently ingested as a decoction with alcohol or as a tea).
Ma KF, Zhang XG, Jia HY. (2014). CYP1A2 polymorphism in Chinese patients with acute liver injury induced by Polygonum multiflorum. Genet Mol Res. (Among 43 cases of Polygonum multiflorum hepatotoxicity tested for CYP1A2 variants, 47% of cases vs 28% of controls had CYP 1A2*1C, a variant associated with reduced activity).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, four were due to unnamed Chinese herbs but none were attributed specifically to Polygonum multiflorum, Fo-Ti or Shou Wu Pian).
Teschke R, Zhang L, Long H, Schwarzenboeck A, Schmidt-Taenzer W, Genthner A, Wolff A, et al. (2015). Traditional Chinese medicine and herbal hepatotoxicity: a tabular compilation of reported cases. Ann Hepatol. (Review of literature on hepatotoxicity of traditional Chinese Medicines includes details of the 25 cases attributed to Polygonum multiflorum published by Jung et al [2011]).
Zhu Y, Li YG, Wang JB, Liu SH, Wang LF, Zhao YL, Bai YF, et al. (2015). Causes, features, and outcomes of drug-induced liver injury in 69 children. Gut Liver. (Among 69 children hospitalized for drug induced liver injury between 2009 and 2012, the most frequent causes were antibiotics [n=18] and Chinese Traditional Medicines [n=15] including 3 cases due to Polygonum multiflorum).
Bounda GA, Feng YU. (2015). Review of clinical studies of Polygonum multiflorum Thunb. and its isolated bioactive compounds. Pharmacognosy Res. (Review of the preparation, chemical constituents, pharmacology, clinical efficacy and hepatotoxicity of Polygonum multiforum).
Li X, Qu C, He Q, Chen W, Zhang X, Liu X, Liu Y, et al. (2015). Acute hepatitis induced by a Chinese herbal product Qibao Meiran Wan: a case study. Int J Clin Exp Med. (26 year old Chinese man developed fatigue followed by jaundice one month after starting Qibao Meiran Wan for hair growth [bilirubin 3.2 mg/dL, ALT 1674 U/L, Alk P 110 U/L], resolving within a month of stopping the herbal product which was labelled as containing 8 different botanicals, one of which was Polygonum multiflorum).
Douros A, Bronder E, Andersohn F, Klimpel A, Kreutz R, Garbe E, Bolbrinker J. (2016). Herb-Induced Liver Injury in the Berlin Case-Control Surveillance Study. Int J Mol Sci. (Among 198 patients with suspected drug induced liver injury seen at Berlin Hospitals and enrolled in a prospective database, 10 were attributed to herbal supplements but none were attributed to Shou Wu Pian or Polygonum multiflorum).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists 8 cases of jaundice and “numerous” cases of hepatitis associated with Polygonum multiflorum and Shou Wu Pian).
Li H, Wang X, Liu Y, Pan D, Wang Y, Yang N, Xiang L, et al. (2017). Hepatoprotection and hepatotoxicity of Heshouwu, a Chinese medicinal herb: Context of the paradoxical effect. Food Chem Toxicol. (Review of the methods of preparation and in vivo and in vitro effects of two forms of Polygonum multiflorum—Sheng Shou Wu [dried roots] and Zhi He Shou Wu [boiled roots with black soybean] used in Traditional Chinese Medicine which have different concentrations of basic constituents and have both hepatoprotective and hepatotoxic potential).
Li CY, He Q, Gao D, Li RY, Zhu Y, Li HF, Feng WW, et al. (2017). Idiosyncratic drug-induced liver injury linked to Polygonum multiflorum: A case study by pharmacognosy. Chin J Integr Med. (41 year old man developed fatigue 2 weeks after starting Polygonum multiflorum for blackening of his hair followed in a week by jaundice [bilirubin 9.6 mg/dL, ALT 766 U/L, Alk P 132 U/L, INR 1.1], resolving within a month of stopping the product which tested positive for the herb).
Wang Y, Wang L, Saxena R, Wee A, Yang R, Tian Q, Zhang J, et al. (2019). Clinicopathological features of He Shou Wu-induced liver injury: This ancient anti-aging therapy is not liver-friendly. Liver Int.
(Among 547 patients hospitalized for drug induced liver injury, 29 cases were attributed to He Shou Wu [Polygonum multiflorum] all of which were hepatocellular with median initial bilirubin of 6.0 mg/dL, ALT 995 U/L, Alk P 165 U/L, median latency of 40 days [range 4-300], 79% were jaundiced, 86% recovered, 1 recurred on rechallenge, 2 had chronic injury and 1 [3%] died) .
Jing J, Wang RL, Zhao XY, Zhu Y, Niu M, Wang LF, Song XA, et al. (2019). Association between the concurrence of pre-existing chronic liver disease and worse prognosis in patients with an herb- “Polygonum multiflorum” thunb. induced liver injury: a case-control study from a specialised liver disease center in China. BMJ Open. (Among 5703 patients hospitalized for drug induced liver injury, 145 were attributed to Polygonum multiflorum, among whom those with preexisting liver disease [n=33: 23%] had a higher mortality rate [9% vs 1%]).
Liu Y, Wang W, Sun M, Ma B, Pang L, Du Y, Dong X, Yin X, Ni J. (2019). "Polygonum multiflorum"-induced liver injury: clinical characteristics, risk factors, material basis, action mechanism and current challenges. Front Pharmacol. (Review of the clinical uses and hepatotoxicity of Polygonum multiflorum also called Ho Shou Wu in China which is used for detoxification and bowel relaxation and which “tonifies the liver and kidney” and benefits “black beard”).
Li C, Rao T, Chen X, Zou Z, Wei A, Tang J, Xiong P, et al. (2019). HLA-B*35:01 allele Is a potential biomarker for predicting Polygonum multiflorum-Induced liver injury in humans. Hepatology. (Among 26 cases of Polygonum multiflorum hepatotoxicity 88% had at least one copy of the HLA-B*35:01 allele compare to 12% of 33 patients with other forms of drug induced liver injury and 5% of normal controls).
Aithal GP. (2019). Of Potions, poisons, Polygonum, and pre-emptive polymorphism. Hepatology. (Editorial in response to Li [2019]).
Zhang L, Niu M, Wei AW, Tang JF, Tu C, Bai ZF, Zou ZS, et al. (2020). Risk profiling using metabolomic characteristics for susceptible individuals of drug-induced liver injury caused by Polygonum multiflorum. Arch Toxicol. (Metabolomics identified 25 metabolites in pretreatment serum that separated 6 Polygonum multiflorum treated subjects who developed evidence of hepatoxicity from 30 who tolerated therapy, the metabolites being involved in glycerophospholipid, sphingolipid, fatty acid, histidine and aromatic amino acid metabolic pathways).
Yang WN, Pang LL, Zhou JY, Qiu YW, Miao L, Wang SY, Liu XZ, et al. (2020). Single-nucleotide polymorphisms of HLA and Polygonum multiflorum-induced liver injury in the Han Chinese population. World J Gastroenterol. (Use of single-nucleotide polymorphisms identified HLA-B*35:01 to be associated with73 cases of polygonum multiflorum hepatotoxicity [allele frequency 0.41] compared to 118 cases if other drug induced liver injury [0.12] and to Han population controls [0.027]).

## OTHER REFERENCE LINKS

1 Recent References on Shou Wu Pian: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=shou+wu+pian+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Shou Wu Pian: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=shou+wu+pian)